# Fexofenadine

## OVERVIEW

### Introduction

Fexofenadine is a second generation antihistamine that is used for the treatment of allergic rhinitis, angioedema and chronic urticaria. Fexofenadine has not been linked to serum enzyme elevations during therapy or to instances of clinically apparent acute liver injury.

### Background

Fexofenadine (fex" oh fen' a deen) is a second generation antihistamine (H1 receptor blocker) that is used widely to treat allergic symptoms associated with hay fever, seasonal allergies, urticaria, angioedema and atopic dermatitis. Fexofenadine, like other second generation antihistamines, is considered to be nonsedating, and prospective studies have shown that sedation is less common with it than with first generation antihistamines such as diphenhydramine. Fexofenadine was approved for use by prescription in the United States in 1996 and as an over-the-counter medication in 2011. Fexofenadine is one of the most widely used medications with more than 18 million prescriptions filled yearly in addition to considerable nonprescription use. Fexofenadine is available in 30, 60 and 180 mg tablets and capsules in generic forms and under the trade name Allegra. Oral suspensions, extended release tablets, and combinations with pseudoephrine are also available. The typical dose in adults is 30 to 60 mg twice daily or 180 mg once daily. Fexofenadine is often given chronically, at least during allergic season. Common side effects include blurred vision, dry mouth and throat, palpitations, tachycardia, abdominal distress, constipation and headache. Although considered to be a nonsedating antihistamine, fexofenadine can cause mild drowsiness particularly at higher doses. Antihistamines can worsen urinary retention and glaucoma.

### Hepatotoxicity

Fexofenadine use is not generally associated with liver enzyme elevations but terfenadine, a second generation antihistamine that is metabolized in part to fexofenadine, was the attributed cause of several reported cases of clinically apparent liver injury. Terfenadine was also linked to cardiac arrhythmias and prolongation of the QTc interval for which reason it was withdrawn from use in 1997, just as fexofenadine was introduced. Liver injury from terfenadine typically arose after 1 to 5 months and was associated with a hepatocellular pattern of liver enzyme abnormalities without immunoallergic or autoimmune features. Fexofenadine has not been linked to similar cases of cardiac arrhythmias or liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

References on the safety and potential hepatotoxicity of antihistamines are given together after the Overview section on Antihistamines.

Drug Class: Antihistamines

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Fexofenadine – Generic, Allegra®

DRUG CLASS

Antihistamines

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Fexofenadine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Fexofenadine | 153439-40-8 | C32-H39-N-O4.Cl-H | Fexofenadine Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Fexofenadine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Fexofenadine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Fexofenadine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Fexofenadine)